# Trimetrexate

## OVERVIEW

### Introduction

Trimetrexate is a parenterally administered folate antagonist that is used as a second line therapy for severe Pneumocystis jirovecii (previously carinii) pneumonia. Trimetrexate therapy has been associated with transient, mild serum enzyme elevations during therapy, but has not been convincingly linked to instances of acute, clinically apparent liver injury.

### Background

Trimetrexate (trye" me trex' ate) is a folic acid analogue which acts as an antagonist inhibiting the enzymes involved in folate dependent synthetic pathways such as thymidine synthase, dihydrofolate reductase and glycinamide ribonucleotide formyltransferase. Inhibition of these enzymes leads to decrease in intracellular thymidine and purine which interferes with RNA and DNA synthesis and leads to apoptotic cell death in rapidly dividing cells. Trimetrexate is a nonclassical folate antagonist and, unlike methotrexate, is lipid soluble which leads to different pharmacokinetics and tissue distribution. Trimetrexate was developed as an antineoplastic agent and showed some activity against breast, lung and head and neck cancer, but had difficult toxicities and never received approval for these uses in the United States. Trimetrexate is also taken up by pathogens including Pneumocystis jirovecii where it blocks the folate dependent synthetic pathways and causes their death. At the same time, folate being water soluble can partially block the systemic effects of trimetrexate, but is not taken up by the pathogens. For this reason, high doses of trimetrexate combined with leucovorin “rescue” were evaluated as therapy of Pneumocystis jirovecii in patients who were resistant or intolerant of first line anti-Pneumocystis therapies. Trimetrexate was approved for use as a second line therapy of moderate-to-severe Pneumocystis jirovecii pneumonia in immunodeficient patients in the United States in 1993. It remains available as a second line drug for this indication, but has not been widely used. Trimetrexate is available in single use vials of 25 or 200 mg as a powder for reconstitution under the brand name Neutrexin. The recommended dose is 45 mg/m^2^ once daily for 21 days concurrent with leucovorin, orally or intravenously, four times daily for 24 days. When given with leucovorin, trimetrexate is well tolerated, but can cause many of the common side effects of other folate antagonists such as fatigue, nausea, vomiting, anorexia, diarrhea, alopecia, anemia, neutropenia and rash. Uncommon, but potentially serious adverse events include febrile neutropenia, infections, dehydration, renal failure, arrhythmias and peripheral neuropathy.

### Hepatotoxicity

When given without leucovorin protection, trimetrexate therapy is associated with a moderate rate of serum enzyme elevations, serum ALT or AST elevations above 5 times ULN in up to 20% of patients. When given with leucovorin, however, trimetrexate has fewer side effects although serum enzyme elevations can still occur. In clinical trials in patients with HIV infection and Pneumocystis jirovecii pneumonia, ALT elevations above 5 times ULN occurred in 1% to 8% of patients, but were usually no more frequent than with standard therapy using trimethoprim with sulfamethoxazole. The elevations were typically transient, without accompanying symptoms or jaundice and resolved or improved despite continuation of therapy. No instances of clinically apparent acute liver injury attributed to trimetrexate have been reported in the literature. In addition, trimetrexate has not been linked to sinusoidal obstruction syndrome or to reactivation of hepatitis B. Nevertheless, trimetrexate probably has hepatotoxic potential, but because it has limited use, is given for short periods of time and is administered with leucovorin, it has not been convincingly linked to cases of clinically apparent liver injury with jaundice.

Likelihood score: E* (unproven but suspected cause of liver injury).

### Mechanism of Injury

The cause of the serum enzyme elevations that may occur during trimetrexate use is probably direct hepatotoxicity from the folate antagonism. Its hepatic metabolism has not been well defined.

### Outcome and Management

Trimetrexate therapy has been linked to serum enzyme elevations in a small-to-moderate proportion of patients, but these elevations rarely require dose modifications or early discontinuation of treatment. The elevations often decrease even with continuation of treatment. There have been no instances of idiosyncratic liver injury, acute liver failure, chronic hepatitis or vanishing bile duct syndrome linked to trimetrexate therapy.

Drug Class: Antineoplastic Agents, Antifolate Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trimetrexate – Neutrexin®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Trimetrexate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Trimetrexate | 52128-35-5 | C19-H23-N5-O3 | Trimetrexate chemical structure
Folate | 6484-89-5 | C19-H18-N7-O6.Na | Folate chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 18 April 2016

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; trimetrexate is listed as an antineoplastic agent that has not been associated with liver injury).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; trimetrexate is not discussed).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Folic acid analogs. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1690-94. (Textbook of pharmacology and therapeutics).
Lin JT, Bertino JR. Trimetrexate: a second generation folate antagonist in clinical trial. J Clin Oncol 1987; 5: 2032-40. (Review of the chemical structure and mechanism of action of trimetrexate and summary of pilot studies in breast, lung and head and neck cancers, mentions that toxicity is largely myelosuppression, but gastrointestinal, renal and cutaneous adverse events can occur: “transient elevation of liver enzymes has also been reported”). 2960788
Grem JL, Ellenberg SS, King SA, Shoemaker DD. Correlates of severe or life-threatening toxic effects from trimetrexate. J Natl Cancer Inst 1988; 80: 1313-8. (Analysis of side effects in 272 patients with cancer treated with trimetrexate suggested that leukopenia and mucositis were dose related and that patients with low baseline serum protein levels were more likely to suffer severe side effects; ALT or AST elevations above 5 times ULN occurring in 22% of subjects with serum albumin 3.2 g/dL or below, but only 5-9% with normal values). 2971817
Balis FM, Patel R, Luks E, Doherty KM, Holcenberg JS, Tan C, Reaman GH, et al. Pediatric phase I trial and pharmacokinetic study of trimetrexate. Cancer Res 1987; 47: 4973-6. (Among 30 children with cancer treated with several doses of trimetrexate, dose limiting toxicities were myelosuppression, mucositis, rash and “mild, dose-related, transient elevations in serum transaminases [2- to 3-fold higher than baseline]”). 2957048
Bertino JR. Trimetrexate: overall clinical results. Semin Oncol 1988; 15 (2 Suppl 2): 50-1. (Commentary on preliminary studies of trimetrexate in several solid tumors mentions promising results in lung, breast and head and neck cancers; toxicities described as very much like those with methotrexate). 2966986
Allegra CJ, Kovacs JA, Drake JC, Swan JC, Chabner BA, Masur H. Activity of antifolates against Pneumocystis carinii dihydrofolate reductase and identification of a potent new agent. J Exp Med 1987; 165: 926-31. (In vitro studies of rat and P. jirovecii dihydrofolate reductase showed superior inhibitory activity of trimetrexate compared to trimethoprim and pyrimethamine and in vivo studies demonstrated its effectiveness in rat P. jirovecii infection). 2950200
Allegra CJ, Chabner BA, Tuazon CU, Ogata-Arakaki D, Baird B, Drake JC, Simmons JT, et al. Trimetrexate for the treatment of Pneumocystis carinii pneumonia in patients with the acquired immunodeficiency syndrome. N Engl J Med 1987; 317: 978-85. (Among 49 patients with HIV infection and Pneumocystis jirovecii pneumonia treated with trimetrexate and leucovorin, 63-71% responded including patients who were refractory or intolerant to conventional therapy; side effects were infrequent while ALT or AST elevations above 5 times ULN occurred in 4 [8%] patients, they resolved despite continuing therapy). 2958710
Hughes WT. Pneumocystis carinii pneumonitis. N Engl J Med 1987; 317: 1021-3. (Editorial on Pneumocystis jirovecii infection in response to article by Allegra [1987: NEJM]). 2958709
Eisenhauer EA, Zee BC, Pater JL, Walsh WR. Trimetrexate: predictors of severe or life-threatening toxic effects. J Natl Cancer Ins. 1988; 80: 1318-22. (Analysis of 68 patients treated with trimetrexate in cancer chemotherapy trials found that low serum protein levels and metastatic liver disease were predictive of likelihood of severe side effects). 2971818
Trimetrexate for Pneumocystis carinii pneumonia. Med Lett Drugs Ther 1989; 31: 5-6. (Concise summary of the mechanism of action and efficacy of trimetrexate with leucovorin as therapy of Pneumocystis jirovecii pneumonia shortly after its approval for this use in the US, mentions that when combined with leucovorin, is well tolerated; no mention of ALT elevations). 2521370
Sattler FR, Allegra CJ, Verdegem TD, Akil B, Tuazon CU, Hughlett C, Ogata-Arakaki D, et al. Trimetrexate-leucovorin dosage evaluation study for treatment of Pneumocystis carinii pneumonia. J Infect Dis 1990; 161: 91-6. (In a dose finding study of trimetrexate and leucovorin in 53 patients with Pneumocystis jirovecii pneumonia, ALT elevations above 5 times ULN occurred in 15 patients [28%] with peak values of 184 to 1205 U/L, but no patients developed jaundice, and all improved despite continuing therapy, none requiring early discontinuation because of liver injury). 2136905
Grem JL, King SA, Costanza ME, Brown TD. Hypersensitivity reactions to trimetrexate. Invest New Drugs 1990; 8: 211-4. (5 patients had immediate hypersensitivity reactions to infusions of trimetrexate; symptoms included immediate hypotension, loss of consciousness, flushing, fever, and periorbital edema; all resolved with stopping and either corticosteroids or antihistamines or both; no mention of ALT elevations or hepatotoxicity). 2143501
Helweg-Larsen J, Benfield T, Atzori C, Miller RF. Clinical efficacy of first- and second-line treatments for HIV-associated Pneumocystis jirovecii pneumonia: a tri-centre cohort study. J Antimicrob Chemother 2009; 64: 1282-90. (Among 1122 HIV infected patients with P. jirovecii pneumonia treated at 3 European centers between 1989 and 2004, most were treated with trimethoprim/sulfamethoxazole [81%] or pentamidine [7%] and few with trimetrexate/leucovorin; no discussion of adverse reactions). 19858161
Short CE, Gilleece YC, Fisher MJ, Churchill DR. Trimetrexate and folinic acid: a valuable salvage option for Pneumocystis jirovecii pneumonia. AIDS 2009; 23: 1287-90. (Among 14 patients with refractory Pneumocystis jirovecii pneumonia treated with trimetrexate and leucovorin, the response rate was 71% and there were no early discontinuations for side effects; no mention of ALT elevations or hepatotoxicity). 19424049

## OTHER REFERENCE LINKS

1. Recent References on Trimetrexate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Trimetrexate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Trimetrexate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Trimetrexate)